# Avanafil

## OVERVIEW

### Introduction

Avanafil is a selective inhibitor of phosphodiesterase type 5 (PDE5) and is used as therapy of erectile dysfunction. Avanafil is a relatively new medication and has yet to be linked to instances of serum enzyme elevations or with clinically apparent acute liver injury.

### Background

Avanafil (a van' a fil) is a selective inhibitor of phosphodiesterase type 5 (PDE5) which mediates the breakdown of cyclic guanosine monophosphate (cGMP), inducing smooth muscle relaxation in the corpus cavernosum of the penis and in the pulmonary vasculature where this specific phosphodiesterase is found. Avanafil is effective in prolonging erection and was approved for use in the United States in 2012. Avanafil is available in tablets of 50, 100 and 200 mg under the brand name of Stendra. The recommended dose is 100 mg as a single dose as needed one-half hour before sexual activity. The dose can be increased or decreased based upon effect and tolerance with a recommended maximum frequency of once daily and maximum dosage of 200 mg. Common side effects include dizziness, headache, flushing, hypotension, rhinitis and dyspepsia. Rare, but potentially serious adverse events include vision and hearing loss, hypotension, cardiovascular events and priapism.

### Hepatotoxicity

Avanafil has had limited general use, but in premarketing studies it was not associated with cases of clinically apparent liver injury and serum enzyme elevations were not reported. The related PDE5 inhibitors, sildenafil and tadalafil, have been linked to isolated, rare instances of acute liver injury and jaundice. The latency to onset ranged from a few days to 3 months and the pattern of injury was usually cholestatic. Autoimmune and immunoallergic features were not observed and all cases were self-limited without residual injury or acute liver failure. Whether avanafil can cause a similar form of acute liver injury is not yet known.

Likelihood score: E* (unproved but suspected rare cause of clinically apparent liver injury).

### Mechanism of Injury

While avanafil has not been associated with hepatotoxicity, its potential for causing hypotension and use in patients with cardiac disease may lead to instances of acute ischemic liver injury. Avanafil, like the other PDE5 inhibitors, is metabolized in the liver via the cytochrome P450 system (CYP 3A4).

### Outcome and Management

There is no known cross sensitivity between avanafil and the other PDE5 inhibitors currently in use in the United States. However, switching to another PDE5 inhibitor after an episode of clinically apparent liver injury should be done with caution.

References to the safety and potential hepatotoxicity of avanafil are provided in the Overview section on PDE5 Inhibitors.

Drug Class: PDE5 Inhibitors

Other Drugs in the Class: Sildenafil, Tadalafil, Vardenafil

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Avanafil – Stendra ®

DRUG CLASS

PDE5 Inhibitors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Avanafil)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Avanafil | 330784-47-9 | C23-H26-Cl-N7-O3 | Avanafil Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Avanafil: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Avanafil/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Avanafil: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Avanafil)